# Vimseltinib

## OVERVIEW

### Introduction

Vimseltinib is a small molecule inhibitor of the colony stimulating factor 1 receptor and is used to treat adults with symptomatic tenosynovial giant cell tumor that is not amenable to surgical resection. Vimseltinib is associated with transient elevations in serum aminotransferase levels during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Vimseltinib (vim sel’ ti nib) is an orally available, specific inhibitor of the colony stimulating factor 1 (CSF1) receptor that is used in the therapy of adults with tenosynovial giant cell tumor not eligible for surgical resection. Tenosynovial giant cell tumor (TGCT) is a rare, non-malignant, but locally aggressive tumor of synovial tissues of joints, bursa, and tendon sheaths. Surgery is the standard approach to therapy, but it can result in joint injury and functional disability only to be followed by recurrence. Genetic analyses have shown that the tumors harbor a gene translocation of CSF1 that leads to its overexpression that results in unregulated growth of the tumor cells. Inhibition of CSF1 activity by blocking its receptor is a feasible approach to therapy of patients in whom surgery has failed or is not appropriate. Vimseltinib was found to inhibit CSF1 kinase activity with a high degree of specificity and to suppress growth of tumor cells with CSF1 translocation in cell culture. In a pre-registration controlled trial, vimseltinib led to objective response rates of 40% within 6 months compared to none with placebo. Vimseltinib was approved in the United States in 2025 as treatment for adults with symptomatic TGCT for which surgical resection would potentially cause worsening functional limitation or severe morbidity. Vimseltinib is available in capsules of 14, 20 and 30 mg under the brand name Romvimza. The recommended dose is 30 mg orally twice weekly (with individual doses separated by at least 72 hours). Side effects are common and include fatigue, nausea, pruritus, rash, and peripheral, facial or periorbital edema. Laboratory abnormalities can include increases in serum aminotransferases, creatine phosphokinase, and cholesterol, as well as decreases in neutrophils and total white cell counts. Less frequent but potentially severe adverse events include allergic reactions to color additives, increases in serum creatinine, hepatotoxicity, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure placebo-controlled trial in 123 adults with tenosynovial giant cell tumors, elevations in serum ALT levels arose in 24% of patients on vimseltinib vs 16% on placebo, and AST levels in 92% vs 10%. However, none of the values of ALT or AST were above 5 times ULN in either group. In a pooled safety cohort of 253 patients treated with vimseltinib, one patient discontinued therapy because of AST elevations, but no patient was diagnosed with drug-induced liver injury or experienced clinically apparent liver injury with jaundice. Furthermore, the higher rates of AST than ALT elevations, together with reported high rates of CPK elevations, suggest that some of the AST abnormalities were from muscle or extrahepatic tissues rather than liver. Because pexidartinib, the initial CSF1 receptor inhibitor approved for the same indication, was linked to episodes of severe acute liver injury, the product label for vimseltinib recommends avoiding therapy in patients with preexisting liver disease or liver test abnormalities, and monitoring liver tests before and during therapy. Since approval and clinical availability of vimseltinib, there have been no published case reports of clinically apparent liver injury with jaundice attributed to its use, but clinical experience with the agent has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from vimseltinib therapy are unknown but may be due to direct toxicity of the kinase inhibition. The relative lack of hepatotoxicity of vimseltinib may relate to its high degree of specificity, having little activity against other kinases. Vimseltinib is metabolized primarily by oxidation, demethylation, and dealkylation and is minimally metabolized by hepatic microsomal enzymes (CYPs). It does interact with several hepatocyte transporters and can increase serum levels of drugs that are substrates of P-glycoprotein, breast cancer resistance protein, and the organic cation transporter 2. Such drugs should be avoided or not taken at the same time (within 4 hours) as vimseltinib.

### Outcome and Management

The product label for vimseltinib recommends monitoring of liver tests before and during therapy including twice monthly for the first 2 months, once every 3 months for the first year, and as clinically indicated thereafter. If serum aminotransferase elevations above 5 times the upper limit of normal arise or if any elevations are accompanied by jaundice or symptoms, therapy should be at least temporarily discontinued. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between vimseltinib and other kinase inhibitors, including those that target the CSF1 receptor (pexidartinib).

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Kinase Inhibitors Used for Tenosynovial Giant Cell Tumor: Pexidartinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vimseltinib – Romvimza®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vimseltinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vimseltinib | 1628606-05-2 | C23H25N7O2 | SID: 393896423

## ANNOTATED BIBLIOGRAPHY

References updated: 31 August 2026

Abbreviations: CSF1, colony stimulating factor 1; ULN, upper limit of the normal range; TGCT, tenosynovial giant cell tumor

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as vimseltinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not vimseltinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2025.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/219304Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of vimseltinib in support of its FDA approval for treatment of tenosynovial giant cell tumor (TGCT), mentions that in the pre-registration controlled trial in 123 patients with TGCT, ALT elevations arose in 24% of vimseltinib recipients vs 16% of placebo controls, AST in 92% vs 10%, and alkaline phosphatase in 14% vs 8%, but none of the enzyme elevations were above 5 times ULN, none were associated with jaundice, and only one AST elevation led to drug discontinuation, so that, unlike pexidartinib, it has not been linked to cases of drug-induced liver injury).
Caldwell TM, Ahn YM, Bulfer SL, Leary CB, Hood MM, Lu WP, Vogeti L, et al. Discovery of vimseltinib (DCC-3014), a highly selective CSF1R switch-control kinase inhibitor, in clinical development for the treatment of tenosynovial giant cell tumor (TGCT). Bioorg Med Chem Lett. 2022;74:128928. (Structure-activity relationship optimization of molecular candidates with activity against the Colony Stimulating Factor 1 [CSF1] receptor identified a potent and specific tyrosine kinase inhibitor of the CSF1 receptor with promise for the treatment of TGCT). 35961460
Gelderblom H, Bhadri V, Stacchiotti S, Bauer S, Wagner AJ, van de Sande M, Bernthal NM, et al; MOTION investigators. Vimseltinib versus placebo for tenosynovial giant cell tumour (MOTION): a multicentre, randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. 2024;403(10445):2709-2719. (Among 123 patients with TGCT not amenable to surgery treated with vimseltinib [30 mg] or placebo twice weekly for 25 weeks, objective response rates were 40% vs none, and ALT elevations occurred in 11% vs 3% but none were above 5 times ULN or were accompanied by jaundice). 38843860
Gelderblom H, Razak AA, Taylor MH, Bauer TM, Wilky B, Martin-Broto J, Gonzalez AF, et al. CSF1R inhibition in patients with advanced solid tumors or tenosynovial giant cell tumor: a phase I study of vimseltinib. Clin Cancer Res. 2024;30:3996-4004. (In a dose finding study of vimseltinib in 32 patients with TGCT not amenable to surgery, ALT elevations arose in 22% of patients but were above 5 times ULN in only one and no patient had bilirubin elevations or met criteria of drug-induced liver injury). 38995311
Vimseltinib (Romvimza) for tenosynovial giant cell tumor. Med Lett Drugs Ther. 2025;67(1726):e66-e67. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of vimseltinib shortly after its approval for use in the United States, mentions that ALT and AST elevations can occur during therapy and that monitoring of liver tests should be done before and during treatment, but that, unlike pexidartinib [the initial CSF-1 receptor inhibitor approved for use in TGCT], cases of serious liver injury have not been reported with vimseltinib). 40254734
Lee A. Vimseltinib: first approval. Drugs. 2025;85:985-989. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of vimseltinib shortly after its approval for use in the United States, states that serious adverse events arose in only 2.4% of treated patients and that AST elevations were frequent but none were above 5 times ULN or resulted in drug discontinuation). 40415163
Stacchiotti S, Blay JY, Rutkowski P, Gelderblom H, Falcón A, Le Cesne A, Desai J, et al. Vimseltinib for patients with tenosynovial giant cell tumor: A multicenter, open-label, phase 2 trial. Cancer. 2026;132:e70564. (Among 66 patients with TGCT not amenable to surgery treated with vimseltinib in an open-label trial for 0.5 to 3 years, the overall objective response rate at 25 weeks was 33% and ALT elevations arose in 8 patients [12%], but none were above 5 times ULN, and none were accompanied by jaundice or resulted in drug discontinuation). 42643031

## OTHER REFERENCE LINKS

1. Recent References on Vimseltinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=vimseltinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Vimseltinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=vimseltinib)